# Mistletoe

## OVERVIEW

### Introduction

Mistletoe is the common name for two different and unrelated plants used in traditional medicine: American mistletoe (Phoradendron leucarpum) and European mistletoe (Viscum album). American mistletoe is native to North America and is known predominantly as a Christmas decoration, but extracts of the plant have been used to treat hypotension and other disorders. European mistletoe is a parasitic vine found in Europe, Northern Africa and Southern Asia that has been used to treat headaches and seizures and more recently as therapy of cancer. Both the American and European mistletoe can be toxic in high doses, but neither has been convincingly shown to cause clinically apparent liver injury when given in conventional doses.

## American Mistletoe

### Background

American mistletoe (Phoradendron leucarpum) is an evergreen, semiparasitic plant native to North America that typically grows on poplar or apple trees and becomes prominently visible when the parasitized tree loses its leaves in winter. American mistletoe is commonly used as a Christmas decoration, but infrequently as an herbal product. The leaves, stems and berries were used in traditional medicine to treat hypotension, constipation and as an abortifacient. The active component of American mistletoe appears to be a phoratoxin which causes vasoconstriction, perhaps the basis for its purported uses. High doses can induce delirium, hallucinations, bradycardia, hypertension and cardiac arrest. Nevertheless, there have been few reports of serious complications from accidental ingestion of a up to 20 leaves or up to 5 berries of American mistletoe. Accidental ingestions are most frequent in December and occur mostly in children, but symptoms are uncommon and most children are managed as outpatients without therapy. American mistletoe is available as an oral extract in several forms and is purported to be beneficial for hypotension and constipation, but its clinical efficacy has not been shown in prospective clinical trials. There is no recommended dose. Side effects can include gastrointestinal discomfort, nausea, vomiting and drowsiness. American mistletoe is believed to be embryotoxic and an abortifacient.

### Hepatotoxicity

Mistletoe in conventional oral doses is typically described as having no adverse side effects, with no mention of either hepatotoxicity or ALT elevations. Adverse events have been reported from large national registries or poison registries, but usually without details of the timing, duration and severity of the abnormalities. In the literature on mistletoe induced liver injury, the form of mistletoe (whether American or European) has rarely been documented.

Likelihood score: E (while capable of causing cardiac and neurologic toxicity in high doses, it is unlikely a cause of clinically apparent liver injury).

Other names: Golden bough, birdlime

## European Mistletoe

### Background

European mistletoe (Viscum album) is a parasitic vine that grows on several types of deciduous trees found in Europe, Northern Africa, and Southern Asia. Orally administered extracts of the leaves, stems and berries have been used in traditional medicine to treat headaches, seizures, hypertension and menopausal symptoms. The active components of European mistletoe appear to be its main glycoprotein lectins (ML-1, -2 and -3) which have antiinflammatory, immunomodulatory and antineoplastic activity in vitro. The concentrations and distribution of the main lectins vary by geographic site, the species of tree that it parasitizes, and the timing and local conditions of its harvest. Recently, purified and recombinant forms of mistletoe lectin 1 (viscumin) have been found to be a potent ribosome inactivating protein with antineoplastic activity in vitro and in animal models of cancer. Parenteral formulations of purified mistletoe lectins (viscumin, ML-1) have been developed and evaluated as a possible therapy of cancer. A recombinant form of mistletoe main lectin 1 (aviscumine) has been used extensively in Europe but was never approved for use in the United States. Randomized controlled trials of mistletoe in cancer were largely negative and used mistletoe in combination with conventional antineoplastic agents. Nevertheless, these trials demonstrated that aviscumine, even in high doses, was reasonably well tolerated. European mistletoe is not approved for therapy of any condition in the United States but products are available as dietary supplements, some of which are approved for use in Canada and the European Union. Mistletoe is available both in solution for injection and as oral tablets or capsules. In addition, It is commonly marketed in combination with other herbs, minerals and vitamins in multi-ingredient dietary supplements. Side effects can include gastrointestinal discomfort, nausea, vomiting, chills, fever, pruritus, headache and fatigue.

### Hepatotoxicity

In several small, rather short term clinical trials, mistletoe in conventional oral doses was typically described as having no adverse side effects, with no mention of either hepatotoxicity or ALT elevations. Isolated reports of serum enzyme elevations during mistletoe therapy have been listed in large national registries, but usually without details of the timing, duration and severity of the abnormalities. In multiple trials of parenteral mistletoe extracts and purified or recombinant viscumin, liver injury and ALT elevations were not described. In the rare cases of clinically apparent liver injury attributed to mistletoe, the European form (Viscum album) was used and patients were exposed to other potential hepatotoxic herbs (skullcap, kudzu) making the role of mistletoe uncertain. Thus, mistletoe has not been shown convincingly to cause clinically apparent liver injury, at least in the doses used in humans.

Likelihood score: E (while capable of causing cardiac and neurologic toxicity in high doses, it is unlikely a cause of clinically apparent liver injury).

Other names: Birdlime, All-heal

### Mechanism of Injury

The mechanism by which European mistletoe might cause liver injury is unknown, but is has biologically active glycoprotein lectins, alkaloids or monoterpene glucosides that appear to have direct toxicity that is largely cardiac.

### Outcome and Management

Hepatotoxicity from mistletoe is rare and generally mild; cases have been self-limiting upon stopping the herbal.

Drug Class: Herbal and Dietary Supplements

Other names: Birdlime, All-heal

## CASE REPORT

### Case 1. Acute hepatocellular liver injury attributed to mistletoe.(1)

A 49 year old woman develop nausea, fatigue and abdominal discomfort several weeks after starting an herbal tablet for anxiety which was reported to be a mixture of mistletoe, skullcap, motherwort, kelp and wild lettuce. She had no history of liver disease and denied taking other medications. Laboratory tests showed a total bilirubin of 1.5 mg/dL, AST greater than 250 U/L, alkaline phosphatase 123 U/L. Tests for hepatitis B surface antigen and a cholecystogram were normal. A liver biopsy showed portal inflammation. The herbal product was stopped and she recovered slowly. Six months later, all blood tests were normal (Table). She had a recurrence of symptoms two years later and liver tests were mildly abnormal. She had restarted the herbal product, and at this point, it was implicated in causing the injury. A liver biopsy again showed portal inflammation and foci of single hepatocyte necrosis. Liver tests returned to normal after stopping the herbal product again. She then underwent a formal challenge study with the herbal tablets and rapidly developed symptoms along with rises in serum enzymes and bilirubin. Another liver biopsy showed inflammation and hepatocyte necrosis. In follow up all tests returned to normal as did liver histology as shown by another liver biopsy.

#### Key Points

Medication: | Herbal tablets containing mistletoe (90 mcg), kelp, motherwort, skullcap and wild lettuce: one tablet daily
Pattern: | Hepatocellular
Severity: | Mild (anicteric)
Latency: | Several weeks
Recovery: | 6 months
Other medications: | None listed

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Initiated therapy with an herbal product for anxiety
~4 weeks | 0 | >250 | 123 | 2.5 | Symptoms fatigue, nausea, pain
| 6 months | 23 | 55 | 0.8
~4 weeks | 0 | 62 | 72 | 0.8 | Reexposure: symptoms
10 days | 0 | >250 | 144 | 2.2 | Rechallenge: symptoms
| 8 months | 38 | 61 | 0.4
| 20 months | 36 | 70 | 0.5
Upper Limit of Normal | | ~40 | ~100 | 1.2

#### Comment

This was the first and one of the only reports of liver injury attributed to mistletoe. While not specifically mentioned, the herb was most likely European mistletoe (Viscum album). Strikingly, the injury recurred on reexposure and then a formal rechallenge was conducted with liver biopsies at the time of injury as well as in recovery. While there was good evidence of recurrent injury, attribution to mistletoe has been questioned. Weakening the evidence for mistletoe being response was the lack of previous reports of any liver injury associated with its use as well as the low dose include in the tables (90 mg daily when the recommended dose was 2 to 8 grams daily. Finally, the herbal product being taken also included skullcap which has been linked to rare episodes of liver injury and might well have included other potential hepatotoxins. Finally, this report was from 1981 before the availability of tests for hepatitis A, C or E and before modern imaging techniques such as ultrasound, CT and MRI.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mistletoe – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/european-mistletoe) [European]

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/ency/article/002883.htm)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mistletoe | 84929-55-5 | Herbal | Not Applicable

## CITED REFERENCE

1 Harvey J, Colin-Jones DG. (1981). Mistletoe hepatitis. Br Med J (Clin Res Ed).

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not mistletoe).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of mistletoe).
Harvey J, Colin-Jones DG. (1981). Mistletoe hepatitis. Br Med J (Clin Res Ed).
(49 year old woman developed liver injury after taking a multi-ingredient dietary supplement containing mistletoe, skullcap, kelp, wild lettuce and motherwort [bilirubin 2.5 mg/dL, AST >250 U/L, Alk P 123 U/L], which resolved within 6 months, and had a second episode after restarting the herbal product and after recovering had another recurrence on rechallenge with the product; the authors attributed the injury to mistletoe, but the rechallenge was with the same multi-ingredient product) .
Fletcher-Hyde F. (1981). Mistletoe hepatitis. Br Med J (Clin Res Ed). (Letter in response to Harvey and Colin-Jones [1981] questioning whether the liver injury was due to mistletoe, which was used in a very low dose and has not been linked to hepatic injury previously).
Farnworth NR. (1981). Mistletoe hepatitis. Br Med J (Clin Res Ed). (Letter in response to Harvey and Colin-Jones [1981] questioning whether the liver injury was due to mistletoe, mentioning that none of the ingredients in the product have been linked to liver injury in animals or humans so that the product might have contained a contaminant that was hepatotoxic).
(1982). Baleful mistletoe. Lancet. (Editorial on the report of Harvey and Colin-Jones [1981] and the subsequent controversy about its hepatotoxin potential refers to it as Viscum album, the European variety).
Stirpe F. (1983). Mistletoe toxicity. Lancet. (Letter in response to Lancet editorial [1982] mentioning that mistletoe contains a toxin lectin called viscumin which varies in concentration among different mistletoe leaves and has unknown but suspected toxicity for humans).
Hall AH, Spoerke DG, Rumack BH. (1986). Assessing mistletoe toxicity. Ann Emerg Med. (Among 14 instances of mistletoe ingestion in children from the Rocky Mountain Poison and Drug Center between 1982 and 1985, none became symptomatic and most received no treatment except for ipecac; and review of 318 cases reported to National Poison Control centers, 87% were asymptomatic, 2% had mild effects, only one was considered moderate, and none resulted in serious injury or death).
Bruseth S, Enge A. (1992). Scullcap--leverskade. Misteltein og leverskade. Tidsskr Nor Laegeforen. (Letter in response to the publication on mistletoe hepatitis by Harvey and Colin-Jones [1981] suggests that it was actually due to skullcap, which has been reported to cause liver injury).
Spiller HA, Willias DB, Gorman SE, Sanftleban J. (1996). Retrospective study of mistletoe ingestion. J Toxicol Clin Toxicol. (Among 92 episodes of mistletoe exposure reported to 3 regional poison control centers between 1990 and 1993, only 11 [12%] were associated with symptoms including gastrointestinal upset in 6, mild drowsiness in 2, and 1 case each of eye irritation, ataxia and seizure; were no permanent injuries or deaths).
Krenzelok EP, Jacobsen TD, Aronis J. (1997). American mistletoe exposures. Am J Emerg Med. (Analysis of 1754 exposures to American mistletoe reported to American Poison control centers, 96% were asymptomatic, 92% occurred in children, and less than 1% had any signs of toxicity).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal oil [1], skullcap [2], Chinese herbs [9], valerian [1]; mistletoe is not listed]).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were attributed to herbal products, including Ma huang, usnic acid, kava, chaparral and skullcap; but none were attributed to mistletoe).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 14 attributed to European mistletoe, which were mostly anaphylactoid reactions, fever and irritability; mistletoe was not listed as an agent with liver-related adverse events).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not mistletoe).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; mistletoe is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including the report of mistletoe hepatitis by Harvey and Colin-Jones).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing mistletoe).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not discuss mistletoe).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products none of which were reported as containing mistletoe).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of the international regulatory framework for HDS products and the epidemiology, clinical presentation, diagnosis and cause of HDS associated liver injury with tables and discussion of the most commonly implicated agents, but does not include mention of mistletoe).
Kim HJ, Kim H, Ahn JH, Suk HJ. (2015). Liver injury induced by herbal extracts containing mistletoe and kudzu. J Altern Complement Med. (55 year old Korean man developed fever, abdominal pain and dark urine 1 month after starting a mistletoe extract and 10 days after starting a kudzu root extract [bilirubin 6.3 mg/dL, ALT 1528 U/L, Alk P 160 U/L, INR 1.14], all symptoms resolving and abnormal enzyme levels falling to normal within a week of stopping).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss mistletoe specifically).
Dohmen W, Breier M, Mengs U. (2004). Cellular immunomodulation and safety of standardized aqueous mistletoe extract PS76A2 in tumor patients treated for 48 weeks. Anticancer Res. (Among 12 adults with various cancers treated with mistletoe lectin subcutaneously twice weekly for 48 weeks, NK cells increased and therapy was well tolerated by all patients, ALT and AST levels remaining normal).
Schöffski P, Riggert S, Fumoleau P, Campone M, Bolte O, Marreaud S, Lacombe D, et al., European Organization for Research and Treatment of Cancer New Drug Development Group. (2004). Phase I trial of intravenous aviscumine (rViscumin) in patients with solid tumors. Ann Oncol. (Among 41 patients with advanced refractory solid malignancies treated in a phase 1 dose escalation study of aviscumine [recombinant mistletoe lectin 1] given intravenously twice weekly, adverse events arose with high doses including fatigue, fever, nausea and vomiting, allergic reactions and reversible elevations in serum ALT, AST and alkaline phosphatase).
Augustin M, Bock PR, Hanisch J, Karasmann M, Schneider B. (2005). Safety and efficacy of the long-term adjuvant treatment of primary intermediate- to high-risk malignant melanoma (UICC/AJCC stage II and III) with a standardized fermented European mistletoe (Viscum album L.) extract. Results from a multicenter, comparative, epidemiological cohort study in Germany and Switzerland. Arzneimittelforschung. (Among 329 patients with advanced malignant melanoma treated with fermented European mistletoe subcutaneously 2 to 3 times weekly for at least 3 months, adverse events were uncommon [11%] and included fatigue, fever, allergic reactions and itching; no mention of ALT elevations or hepatotoxicity).
Courtemanche J, Peterson RG. (2006). Beware the mistletoe. CMAJ. (Commentary on the potential toxicity of house plants, particularly for toddlers and children who might try to eat them, including mistletoe berries which can cause severe nausea and vomiting).
Melzer J, Iten F, Hostanska K, Saller R. (2009). Efficacy and safety of mistletoe preparations (Viscum album) for patients with cancer diseases. A systematic review. Forsch Komplementmed. (Systematic review of the literature on mistletoe therapy of cancer identified 18 clinical trials in approximately 6800 patients, overall found little evidence of antineoplastic activity but seemed to improve quality of life; side effect arise in 17.5% of patients but are generally mild-to-moderate and include fatigue, fever, headache, itching and local reactions with one serious event of angioedema; no mention of ALT elevations or hepatotoxicity).
Steele ML, Axtner J, Happe A, Kröz M, Matthes H, Schad F. (2014). Adverse drug reactions and expected effects to therapy with subcutaneous mistletoe extracts (Viscum album L.) in cancer patients. Evid Based Complement Alternat Med. (Among 1923 patients with cancer who received complementary therapy using mistletoe extract, 14.7% had an adverse reaction, which were mostly mild-to-moderate and included headache, fatigue, fever, local reactions and itching; no mention of ALT elevations or hepatotoxicity).
Freuding M, Keinki C, Micke O, Buentzel J, Huebner J. (2019). Mistletoe in oncological treatment: a systematic review: Part 1: survival and safety. J Cancer Res Clin Oncol. (Systematic review of the literature on efficacy of mistletoe in cancer identified 28 publications with a total of 2639 patients with various forms of advanced cancer, mistletoe was usually added to conventional therapy, and while most studies were of low quality, overall there was no evidence that mistletoe therapy had any effect on survival; side effects were usually mild and self-limited and serious adverse events were rare; no mention of ALT elevations or hepatotoxicity).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, mentions mistletoe as being implicated in only one report [Harvey and Colin-Jones 1981] in a patient also taking skullcap, a known hepatotoxin).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to mistletoe).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], but none were attributed to mistletoe).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; mistletoe was implicated in 3 cases but details were not provided).

## OTHER REFERENCE LINKS

1 Recent References on Mistletoe: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mistletoe+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Mistletoe: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mistletoe)